# Miglitol

## OVERVIEW

### Introduction

Miglitol is an alpha glucosidase inhibitor which delays intestinal absorption of carbohydrates and is used as an adjunctive therapy in the management of type 2 diabetes. Miglitol has not been linked to instances of clinically apparent acute liver injury.

### Background

Miglitol is an inhibitor of intestinal alpha glucosidase which results in a decrease or delay in intestinal absorption of starch, disaccharides and dextrin. Miglitol is a deoxynojirimycin derivative similar in structure to glucose that inhibits alpha glucosidase activity in the intestinal brush border, blocking the breakdown of starch and disaccharides to absorbable monosaccharides and leading to a delay in carbohydrate absorption and thus blunting of the postprandial rise in blood glucose. Miglitol was approved for use in the United States in 1996 and was the second α-glucosidase inhibitor (after acarbose) introduced into clinical practice. The current indications are for management of glycemic control in type 2 diabetes used with diet and exercise alone or in combination with other oral hypoglycemic agents or insulin. Miglitol is available generically and under the brand name Glyset in tablets of 25, 50 and 100 mg. The typical initial dose in adults is 25 mg with each meal (with the first bite) followed by a gradual increase to a maximum of 100 mg three times daily. Miglitol causes malabsorption and gastrointestinal side effects are most common and flatulence, diarrhea, abdominal boating and rash. Severe adverse events can include rash and pneumatosis cystoides intestinalis. Hypoglycemia may occur with combinations of miglitol with other oral hypoglycemic agents.

### Hepatotoxicity

In several large clinical trials, serum aminotransferase elevations were no more common with miglitol than with placebo, and all elevations that occurred were asymptomatic and resolved rapidly with stopping therapy. Neither during these studies nor since approval and wide clinical use have reports of clinically apparent liver injury due to miglitol been published. Thus, liver injury from miglitol must be very rare if it occurs at all. There also have been no reports of patients who developed liver injury while on acarbose being switched to miglitol.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why miglitol rarely causes liver injury is not known. Unlike acarbose, miglitol is absorbed orally, but it is rapidly cleared by the kidneys and has minimal hepatic metabolism. While similar to acarbose (which does cause liver injury) in its mechanism of action, miglitol is a structurally distinct.

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass Alpha Glucosidase Inhibitors: Acarbose

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Miglitol – Generic, Glyset®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=miglitol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Miglitol | 72432-03-2 | C8-H17-N-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 12 January 2021

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 575-9. (Textbook of hepatotoxicity published in 1999 mentions that several instances of serum enzyme elevations and at least two cases of liver injury with jaundice have been linked to acarbose use; no mention of miglitol).
Bhardwaj SS, Chalasani NP. Antidiabetic drugs. Cardiovascular and antidiabetic medications. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 611-7. (Review of hepatotoxicity published in 2007 mentions that acarbose has been associated with hepatocellular injury despite the fact that it is minimally absorbed, but that miglitol has not been implicated in causing liver injury).
Powers AC, D’Alessio D. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Hillal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 863-86. (Textbook of pharmacology and therapeutics).
Segal P, Feig PU, Schernthaner G, Ratzmann KP, Rybka J, Petzinna D, Berlin C. (1997). The efficacy and safety of miglitol therapy compared with glibenclamide in patients with NIDDM inadequately controlled by diet alone. Diabetes Care. (Controlled trial of miglitol vs glyburide vs placebo for 24 weeks in 201 patients with diabetes; 4 patients had elevations of liver enzymes at the end of the study [1 on miglitol, 1 glyburide and 2 placebo], but all 4 had some degree of elevation before treatment initiation).
(1999). Miglitol for type 2 diabetes mellitus. Med Lett Drugs Ther. (Brief review of role of miglitol in type 2 diabetes; "increased aminotransferase activity has not been reported with miglitol"; otherwise, the average cost, efficacy and tolerance of miglitol are similar to acarbose).
Sels JP, Huijberts MS, Wolffenbuttel BH. (1999). Miglitol, a new alpha-glucosidase inhibitor. Expert Opin Pharmacother. (Review of the mechanism of action of miglitol and summary of results of clinical trials; no discussion of side effects).
Campbell LK, Baker DE, Campbell RK. (2000). Miglitol: assessment of its role in the treatment of patients with diabetes mellitus. Ann Pharmacother. (Systematic review of miglitol therapy of diabetes; rates of serum enzyme elevations during therapy with miglitol were low and similar to placebo).
Scott LJ, Spencer CM. (2000). Miglitol: a review of its therapeutic potential in type 2 diabetes mellitus. Drugs. (Systematic review of literature on miglitol; side effects of flatulence [15-24%], diarrhea [7-13%], and abdominal pain [1-3%] were common, partially dose related, and similar to rates with acarbose; "Unlike acarbose, treatment with miglitol was not associated with elevated serum transaminase levels").
Carlson RF. (2000). Miglitol and hepatotoxicity in type 2 diabetes mellitus. Am Fam Physician. (Letter in response to a review article on treatment of diabetes correcting the statement that miglitol causes liver injury similar to that described with acarbose; in studies for up to 12 months, ALT elevations above 3 times the ULN occurred in 3% of acarbose-, but only 1% of miglitol treated patients with diabetes).
Chiasson JL, Naditch L, Miglitol Canadian University Investigator Group. (2001). The synergistic effect of miglitol plus metformin combination therapy in the treatment of type 2 diabetes. Diabetes Care. (Controlled trial of 8 weeks of miglitol vs placebo with or without metformin in 324 patients with diabetes; there were no differences in biochemical test results among the treatment groups and no liver related serious adverse event).
Chitturi S, George J. (2002). Hepatotoxicity of commonly used drugs: nonsteroidal anti-inflammatory drugs, antihypertensives, antidiabetic agents, anticonvulsants, lipid-lowering agents, psychotropic drugs. Semin Liver Dis. (Overview of hepatotoxicity of antidiabetic medications mentions that acarbose has been incriminated in hepatotoxicity, generally arising within 2-8 months of starting therapy with an acute hepatitis-like clinical picture, but that miglitol has not).
van de Laar FA, Lucassen PL, Akkermans RP, van de Lisdonk EH, Rutten GE, van Weel C. (2005). Alpha-glucosidase inhibitors for patients with type 2 diabetes: results from a Cochrane systematic review and meta-analysis. Diabetes Care. (Review of 41 studies, 30 of acarbose, 7 miglitol, 1 voglibose and 3 combined; discusses relative rates of side effects in comparison to placebo overall, but does not mention hepatic effects specifically).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver injury in the US collected from 2004 to 2008, none were attributed to miglitol or acarbose).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 4 were due to troglitazone, but none were attributed to miglitol or other antidiabetic medications).
(2011). Drugs for type 2 diabetes. Treat Guidel Med Lett. (Concise review of the role of current antidiabetes medications in management of type 2 diabetes).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed antidiabetic agents including miglitol).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an antidiabetic agent including miglitol).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, four were attributed to antidiabetic agents, including metformin, sitagliptin and glibenclamide, but none specifically to miglitol).
Yokoh H, Kobayashi K, Sato Y, Takemoto M, Uchida D, Kanatsuka A, Kuribayashi N, et al. (2015). Efficacy and safety of the dipeptidyl peptidase-4 inhibitor sitagliptin compared with alpha-glucosidase inhibitor in Japanese patients with type 2 diabetes inadequately controlled on metformin or pioglitazone alone (Study for an Ultimate Combination Therapy to Control Diabetes with Sitagliptin-1): A multicenter, randomized, open-label, non-inferiority trial. J Diabetes Investig. (Among 119 Japanese adults with type 2 diabetes incompletely controlled on stable doses of oral agents who had the addition of sitagliptin or miglitol, reductions in HbA1c levels were less with miglitol while adverse events were more common [40% vs 10%] and mostly gastrointestinal; no mention of ALT elevations or hepatotoxicity).
Komatsu M, Tanaka N, Kimura T, Fujimori N, Sano K, Horiuchi A, Sugiura A, et al. (2018). Miglitol attenuates non-alcoholic steatohepatitis in diabetic patients. Hepatol Res. (Among 17 adults with type 2 diabetes and nonalcoholic steatohepatitis treated with miglitol for 12 months, ALT and HbA1c levels and body weight decreased overall as did liver biopsy scores for steatosis and inflammation but not for fibrosis or ballooning; there were no serious adverse events and no mention of ALT elevations or hepatotoxicity).
Hedrington MS, Davis SN. (2019). Considerations when using alpha-glucosidase inhibitors in the treatment of type 2 diabetes. Expert Opin Pharmacother. (Review of the role of alpha glucosidase inhibitors in the therapy of type 2 diabetes mentions that side effects are largely gastrointestinal [diarrhea, abdominal pain, flatulence] and are transient and mostly dose dependent; no mention of ALT elevations or hepatotoxicity).
(2019). Drugs for type 2 diabetes. Med Lett Drugs Ther. (Concise review of the mechanisms of action, clinical efficacy, side effects and costs of currently available drugs for type 2 diabetes mentions that miglitol and acarbose must be taken with each meal and can lower HbA1c levels by 0.5-1.0%; side effects are not discussed).

## OTHER REFERENCE LINKS

1 Recent References on Miglitol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Miglitol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Miglitol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Miglitol)